# Phenotypes Of Drug Induced Liver Injury

Drug induced liver injury can be categorized by phenotype or overall clinical characteristics based upon symptoms, signs and laboratory findings. The phenotype describes the specific form of liver disease that the hepatotoxicity resembles. Twelve phenotypes of drug induced liver injury are given below. Not all cases fit neatly into a specific phenotype and some fulfill criteria for two or more different phenotypes. Nevertheless, characterization by phenotype can be helpful in the diagnosis of drug induced liver injury and in assigning causality, particularly when multiple potential injurious agents are being taken or an herbal or unconventional, alternative medication is used. Grouping cases by phenotype may also help to define the pathogenesis of the injury and categorization of cases for genetic and immunological analyses.

1 Acute hepatic necrosis
2 Acute hepatitis
3 Cholestatic hepatitis
4 Mixed hepatocellular-cholestatic hepatitis
5 Enzyme elevations without jaundice
  a Hepatocellular
  b Cholestatic
  c Mixed
6 Bland cholestasis
7 Hepatic steatosis and lactic acidosis
8 Nonalcoholic fatty liver
9 Chronic hepatitis
10 Sinusoidal obstruction syndrome (veno-occlusive disease)
11 Nodular regenerative hyperplasia
12 Hepatic adenoma and hepatocellular carcinoma

The 12 phenotypes can have distinctive immunological features:

1 Immunoallergic
2 Autoimmune

The 12 phenotypes also have adverse outcomes:

1 Acute liver failure
2 Vanishing bile duct syndrome
3 Cirrhosis

Thus, a complete phenotype might be cholestatic hepatitis with immunoallergic features leading to vanishing bile duct syndrome and cirrhosis; or acute hepatitis with autoimmune features (possibly leading to acute liver failure); or chronic hepatitis with autoimmune features (possibly leading to cirrhosis).

Several of the 12 phenotypes are named for and best defined by histological features (bland cholestasis, hepatic steatosis, cirrhosis). In most instances, liver histology can help define the clinical phenotype and can be pathognomic. Nevertheless, the diagnosis and phenotyping can usually be made using clinical features, laboratory tests and noninvasive imaging.

Descriptions of the 12 phenotypes of drug induced liver injury are given in LiverTox along with clinical case histories, typical histological features and, when appropriate, selected references.